# Obeticholic Acid

## OVERVIEW

### Introduction

Obeticholic acid (OCA) is a synthetically modified bile acid and potent agonist of the farnesoid X nuclear receptor (FXR) that is used to treat liver diseases including primary biliary cholangitis. Obeticholic acid has not been linked to elevations in serum enzyme levels during therapy, but has been linked to an increased rate of severe liver related adverse events such as ascites, jaundice and liver failure.

### Background

Obeticholic (oh bet" i koe' lik) acid is a synthetically modified bile acid that is a potent agonist of the farnesoid X nuclear receptor (FXR), a nuclear receptor with major effects on bile acid synthesis and transport as well as lipid metabolism and glucose homeostasis. Obeticholic acid has been shown to improve serum enzymes in several diseases including nonalcoholic steatohepatitis (NASH) and primary biliary cholangitis (PBC, previously known as primary biliary cirrhosis). Obeticholic acid was given provisional approval for use in the United States for primary biliary cholangitis in 2016 and is currently under evaluation in other liver diseases including primary sclerosing cholangitis (PSC) and nonalcoholic steatohepatitis (NASH). Obeticholic acid is available as tablets of 5 and 10 mg under the brand name Ocaliva. The typical initial dose for primary biliary cholangitis is 5 mg once daily which can then be increased to a maximum of 10 mg daily. Patients with advanced cirrhosis (Child's Class B or C) are advised to start at a dose of 5 mg once weekly and increase thereafter based upon tolerance and effect to a maximum of 10 mg twice weekly. Side effects include pruritus, fatigue, nausea and headache. Symptoms of pruritus appear to be less if therapy is started at a low dose and increased gradually. Less common but potentially severe adverse reactions include hypersensitivity reactions and depression.

### Hepatotoxicity

In multiple preregistration clinical trials, obeticholic acid was found to decrease serum enzyme elevations in a high proportion of patients with different liver diseases. Instances of paradoxical worsening of liver disease or further increases in serum ALT or AST were not reported. However, the product label for obeticholic acid includes warnings that serious liver related adverse events occurred more commonly with active therapy than with placebo treatment. In a pooled analysis of 3 placebo controlled trials in patients with primary biliary cholangitis, liver related adverse events were 5.2 per 100 patient exposure years with 10 mg and 2.4 with placebo. Even higher rates occurred with higher doses of obeticholic acid: 19.8 per 100 patient years for 25 mg daily and 54.5 for 50 mg daily. The clinical features, timing of onset, pattern of enzyme elevations and course of these events were not described in detail. Within a little over a year after approval of obeticholic acid as therapy for primary biliary cholangitis, the FDA published a warning letter stating that they had received notification of 19 deaths and 11 cases of severe liver injury in patients taking obeticholic acid, most but not all of whom had preexisting cirrhosis (Case 1). More recently, severe instances of hepatic decompensation have been reported in patients with both primary biliary cholangitis as well as primary sclerosing cholangitis, two similar chronic cholestatic liver diseases.

In patients with normal alkaline phosphatase levels, obeticholic therapy is associated with slight elevations in alkaline phosphatase, but without accompanying changes in serum aminotransferase levels, GGT or bilirubin, suggesting that the increases are due to alkaline phosphatase from other sources (bone, gastrointestinal tract). Therapy with OCA has been associated with development of pruritus in up to one-third of patients, but the appearance or worsening of itching is not usually associated with worsening of the underlying liver disease or increase in bilirubin or bile acid levels (other than OCA). Thus, obeticholic acid has apparent beneficial effects on liver test abnormalities, but has been linked to rare instances of worsening liver disease which may have clinical significance in patients with preexisting cirrhosis, particularly with use of higher doses of OCA.

Likelihood score: B (a rare but potentially severe cause of clinically apparent liver injury occurring mostly in patients with preexisting cirrhosis).

### Mechanism of Liver Injury

The mechanism by which obeticholic acid might cause liver injury is unclear as it is a synthetic bile acid that is concentrated in the liver and interacts with the nuclear receptor FXR. Agonism of FXR leads to a decrease in bile acid synthesis and increase in bile acid and bilirubin transporters.

### Outcome and Management

Patients on obeticholic acid should be monitored with liver tests, including serum bilirubin, ALT, AST and alkaline phosphatase, during the first few months of therapy to assess both its efficacy and safety. Patients with paradoxical worsening of the liver disease, with persistent worsening of serum enzyme elevations and particularly with evidence of hepatic decompensation, should discontinue obeticholic promptly. There does not appear to be cross sensitivity to liver injury or adverse events between obeticholic and other bile acid therapies such as ursodiol.

Other bile acids used in digestive diseases include chenodeoxycholic acid (chenodiol), cholic acid and ursodeoxycholic acid (ursodiol).

Drug Class: Gastrointestinal Agents, Bile Acids

## CASE REPORT

### Case 1. Hepatic decompensation during therapy of primary biliary cholangitis with obeticholic acid.(1)

A 59 year old Hispanic woman with primary biliary cholangitis (PBC) developed worsening jaundice and fatigue 3 months after starting obeticholic acid. She was known to have had autoimmune liver disease for at least 9 years and had been treated in the past with prednisone, mycophenolate mofetil, and ursodiol with only a partial response. Liver histology initially suggested an overlap syndrome of autoimmune hepatitis and PBC, but with time clinical features suggested that she had primary biliary cholangitis alone despite the absence of antimitochondrial antibody. On ursodiol, she had minimal symptoms, but laboratory tests showed alkaline phosphatase levels of 569 to 712 U/L, ALT 87 to 109 U/L and bilirubin of 2.3 to 2.7 mg/dL. Liver biopsy histology demonstrated significant fibrosis (stage 3 of 4) and paucity of bile ducts ("ductopenia"). In mid 2016, she was started on obeticholic acid (OCA) in a dose of 5 mg daily while maintaining a dose of ursodiol of 1.2 grams daily. She developed pruritus which responded minimally to cholestyramine and hydroxyzine. Nevertheless, liver tests improved slightly, with alkaline phosphatase levels decreasing to 372 U/L, ALT to 53 U/L and bilirubin to 2.2 mg/dL (Table). Approximately 3 months after starting OCA, she was found to have worsening jaundice with a bilirubin of 7.6 mg/dL, but with little changes in serum enzymes. Obeticholic acid was stopped while ursodiol was continued. She had no history of previous drug allergies or exposure to viral hepatitis. She did not drink alcohol. She was managed as an outpatient, but serum bilirubin remained elevated and she developed evidence of ascites and mild hepatic encephalopathy. Upper gastrointestinal endoscopy showed small varices. She was treated with lactulose, diuretics, salt restriction and was monitored closely. Over the next six months, her serum bilirubin decreased to pretreatment values, but alkaline phosphatase levels remained high. Approximtely a year after onset, her itching and ascites resolved and she felt that she had returned to her pretreatment clinical status.

#### Key Points

Medication: | Obeticholic acid (5 mg daily)
Pattern: | Worsening jaundice
Severity: | 4+ hepatic decompensation
Latency: | 82 days
Recovery: | Incomplete at 6 months
Other medications: | Ursodiol, cholestyramine, hydroxyzine, bacloften, tramadol, alendronate, calcium, vitamin D

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 109 | 712 | 2.3 | Ursodiol 1.2 g/d
- 2 mo | Pre | 91 | 664 | 2.7
0 | Pre | Obeticholic acid started (5 mg daily)
2 weeks | Pre | 46 | 431 | 2.2 | Itching
1 month | Pre | 50 | 372 | 2.2
2 months | Pre | 52 | 382 | 2.6
3 months | 0 | 79 | 519 | 7.6 | OCA stopped
| 9 days | 53 | 551 | 6.4 | Ascites noted
4 months | 30 days | 51 | 651 | 6.2 | EGD: Varices
5 months | 50 days | 83 | 959 | 4.2 | INR 1.1
6 months | 80 days | 76 | 865 | 3.9 | Lactulose started
9 months | 6 months | 89 | 743 | 2.7
11 months | 8 months | 69 | 445 | 2.6 | Itching resolved
14 months | 11 months | 52 | 362 | 2.4 | Ascites resolved
Normal Values | | <35 | <130 | <1.2

#### Comment

A middle aged woman with primary biliary cholangitis with advanced fibrosis and an inadequate response to ursodiol was started on obeticholic acid shortly after its approval for this indication in the United States. She had an initial slight improvement in liver tests, but then developed jaundice and signs of hepatic decompensation 3 months after having started obeticholic acid. Despite stopping the medication, recovery was slow, and she returned to her previous status only 8 to 11 months later. Sudden unexplained decompensation of liver disease has been described in several patients with chronic cholestatic liver disease such as primary biliary cholangitis and sclerosing cholangitis within a few weeks to several months after starting obeticholic acid. The cause is unknown, but may be dose related and is most frequent in patients with preexisting cirrhosis or advanced fibrosis. Patients with decompensated cirrhosis should be treated with caution, starting at a dose of 5 mg once weekly and advancing the dose gradually and with regular monitoring. The clinical presentation or phenotype of this injury resembles that of spontaneous hepatic decompensation or what is called "acute-on-chronic liver failure."

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Obeticholic Acid – Ocaliva®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=cdfbe0cd-eb15-45a1-ac17-531bcda21aec)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Obeticholic Acid | 459789-99-2 | C26-H44-O4
Cholic Acid | 81-25-4 | C24-H40-O5

## CITED REFERENCES

1 Data provided by Dr. A. Modi, Liver Consultants of Texas, Baylor Scott & White Medical Center.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 December 2019

Abbreviations used: FXR, farnesoid X receptor; NAFLD, nonalcoholic fatty liver disease; NASH, nonalcoholic steatohepatitis; OCA, obeticholic acid; PBC, primary biliary cirrhosis (cholangitis); PSC, primary sclerosing cholangitis.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of obeticholic acid).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Chen J, Raymond K. (2006). Nuclear receptors, bile-acid detoxification, and cholestasis. Lancet. (Commentary on the nuclear receptor FXR, which acts as a bile acid receptor and mediates reduction in bile acid synthesis and increase in update of bile acids from the circulation as well as secretion of bile acids from hepatocytes).
Cipriani S, Mencarelli A, Palladino G, Fiorucci S. (2010). FXR activation reverses insulin resistance and lipid abnormalities and protects against liver steatosis in Zucker(fa/fa) obese rats. J Lipid Res. (In an animal model of obesity and fatty liver, FXR activation using a synthetic bile acid agonist led to less weight gain and reductions in fasting glucose, insulin, triglycerides and ALT levels as well as reduced hepatic fat when compared to placebo).
Mudaliar S, Henry RR, Sanyal AJ, Morrow L, Marschall HU, Kipnes M, Adorini L, et al. (2013). Efficacy and safety of the farnesoid X receptor agonist obeticholic acid in patients with type 2 diabetes and nonalcoholic fatty liver disease. Gastroenterology. (Among 64 patients with diabetes and fatty liver treated with OCA [25 or 50 mg] or placebo once daily for 6 weeks, OCA led to increases in insulin sensitivity and reductions in GGT [~50%] and ALT [~25%], but increases in Alk P and LDL cholesterol; 1 patient on placebo and one of OCA [50 mg] had ALT elevations above 3 times ULN and were withdrawn from therapy).
Neuschwander-Tetri BA, Loomba R, Sanyal AJ, Lavine JE, Van Natta ML, Abdelmalek MF, Chalasani N, et al., NASH Clinical Research Network. (2015). Farnesoid X nuclear receptor ligand obeticholic acid for non-cirrhotic, non-alcoholic steatohepatitis(FLINT): a multicentre, randomised, placebo-controlled trial. Lancet. (Among 141 patients with NASH treated with OCA [25 mg] or placebo daily for 72 weeks, OCA was associated with greater improvements in ALT levels and liver histology, but without a significant increased rate of NASH resolution; pruritus arose in 33% vs 9% of patients, but there was no other evidence of hepatotoxicity or unexplained ALT elevations).
Hirschfield GM, Mason A, Luketic V, Lindor K, Gordon SC, Mayo M, Kowdley KV, et al. (2015). Efficacy of obeticholic acid in patients with primary biliary cirrhosis and inadequate response to ursodeoxycholic acid. Gastroenterology. (Among 165 patients with PBC and Alk P elevations despite ursodiol therapy who were treated with OCA [10, 25 or 50 mg] daily for 3 months, Alk P levels decreased more with OCA [20-25%] than placebo [<5%] and mean ALT, AST and conjugated bilirubin levels improved; side effects included pruritus, but no other liver related symptom or blood test result).
Rinella ME. (2015). Nonalcoholic fatty liver disease: a systematic review. JAMA. (Review of the clinical features, epidemiology, risk factors, incidence, natural history, pathogenesis and therapy of NAFLD and NASH; mentions that OCA was found to have beneficial effects on liver histology, but the effect size was small and similar to that of vitamin E).
Fuchs CD, Traussnigg SA, Trauner M. (2016). Nuclear receptor modulation for the treatment of nonalcoholic fatty liver disease. Semin Liver Dis. (Review of the possible role of FXR modulation as therapy of fatty liver disease).
Pencek R, Marmon T, Roth JD, Liberman A, Hooshmand-Rad R, Young M. (2016). Effects of obeticholic acid on lipoprotein metabolism in healthy volunteers. Diabetes Obes Metab. (Commentary on OCA from the sponsor focusing on effects of OCA in 68 healthy volunteers in two phase 1 trials that showed transient increases in total and LDL cholesterol and decreases in HDL, all of which reversed rapidly on discontinuation; no mention of ALT elevations or hepatotoxicity).
Parés A. (2015). Therapy of primary biliary cirrhosis: novel approaches for patients with suboptimal response to ursodeoxycholic acid. Dig Dis. (Review of current and experimental therapies of PBC including use of OCA; no mention of hepatotoxicity).
Nevens F, Andreone P, Mazzella G, Strasser SI, Bowlus C, Invernizzi P, Drenth JP, et al., POISE Study Group. (2016). A placebo-controlled trial of obeticholic acid in primary biliary cholangitis. N Engl J Med. (Among 216 patients with PBC treated with OCA [5 to 10 mg daily] or placebo for 12 months, serum Alk P levels decreased by 35% and 41% with OCA but only by 4% with placebo, while symptoms of pruritus worsened and serious adverse event rates were more common with OCA [15% vs 4%]).
Center for Drug Evaluation and Research. Application 207999Orig1s00. Medical Review. pp: 212-26: http://www.accessdata.fda.gov/drugsatfda_docs/nda/2016/207999Orig1s000MedR.pdf (Medical review of clinical trials of obeticholic acid in primary biliary cholangitis; mentions a dose related increased rate of hepatic adverse events with therapy).
(2017). Obeticholic acid (Ocaliva) for primary biliary cholangitis. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of OCA shortly after its approval in the US; mentions common side effects of pruritus, fatigue, abdominal pain, rash and arthralgia, and that pooled analyses of 3 controlled trials showed an increase in liver related adverse events per 100 patient years [from 2.4 with placebo to 5.2 with 10 mg, 19.8 with 25 mg and 54.6 with 50 mg daily]).
Markham A, Keam SJ. (2016). Obeticholic Acid: First Global Approval. Drugs. (Review of the structure, mechanism of action, drug development, clinical efficacy and safety of OCA shortly after its approval as therapy of primary biliary cholangitis; mentions common side effects of pruritus [all degree in 56-68% and severe in 19-23%], fatigue, abdominal discomfort, rash, throat pain and arthralgia and rare instances of ascites or hepatic encephalopathy).
Issa D, Wattacheril J, Sanyal AJ. (2017). Treatment options for nonalcoholic steatohepatitis - a safety evaluation. Expert Opin Drug Saf. (Review of the safety of therapies for nonalcoholic steatohepatitis mentions that pruritus is a common dose related side effect of OCA and that rare instances of liver injury have been reported in clinical trials of ursodiol).
Quigley G, Al Ani M, Nadir A. (2018). Occurrence of jaundice following simultaneous ursodeoxycholic acid cessation and obeticholic acid initiation. Dig Dis Sci. (55 year old Hispanic woman with cirrhosis due to PBC treated was started on OCA simultaneous with stopping ursodiol and developed jaundice within 4-5 weeks [bilirubin rising from 0.8 to 13.0 mg/dL, ALT 20 to 42 U/L, Alk P 270 to 517 U/L], resolving with stopping OCA and restarting ursodiol and later tolerating reintroduction of OCA without worsening).
Hameed B, Terrault NA, Gill RM, Loomba R, Chalasani N, Hoofnagle JH, Van Natta ML. (2018). NASH CRN. Clinical and metabolic effects associated with weight changes and obeticholic acid in non-alcoholic steatohepatitis. Aliment Pharmacol Ther. (A secondary analysis of a randomized control trial of OCA in NASH found that the beneficial effects of weight loss on histology and serum enzyme elevations were additive to those of OCA but that other beneficial effects of weight loss did not occur in OCA treated subjects).
Kowdley KV, Luketic V, Chapman R, Hirschfield GM, Poupon R, Schramm C, Vincent C, et al., Obeticholic Acid PBC Monotherapy Study Group. (2018). A randomized trial of obeticholic acid monotherapy in patients with primary biliary cholangitis. Hepatology. (Among 59 patients with PBC intolerant to ursodiol who were treated with OCA [10 or 50 mg daily] or placebo for 3 months, serum Alk P and GGT improved with OCA but not placebo, but pruritus was common occurring in 70% and 94% of OCA treated vs 35% of placebo recipients; 28 subjects were subsequently treated in an open label extension study and enzyme improvements were sustained while no new hepatic adverse events arose).
Al-Dury S, Wahlström A, Panzitt K, Thorell A, Ståhlman M, Trauner M, Fickert P, et al. (2019). Obeticholic acid may increase the risk of gallstone formation in susceptible patients. J Hepatol. (Among 20 patients with gallstones treated with obeticholic acid [25 mg] or placebo daily for 3 weeks before cholecystectomy, OCA was associated with higher FGF-19 and lower C4 and endogenous bile acid levels, resulting in a decreased biliary cholesterol saturation and greater bile acid hydrophobicity index suggesting an increased risk of gallstones with prolonged OCA therapy; gallbladder epithelial cells accounted for the increase in FGF-19 secretion).
Pockros PJ, Fuchs M, Freilich B, Schiff E, Kohli A, Lawitz EJ, Hellstern PA, et al. (2019). CONTROL: A randomized phase 2 study of obeticholic acid and atorvastatin on lipoproteins in nonalcoholic steatohepatitis patients. Liver Int. (Among 84 adults with PBC treated with obeticholic acid [5, 10 or 25 mg] or placebo daily with addition of atorvastatin at week 4, serum LDL cholesterol increased with OCA treatment but levels fell to below baseline after addition of atorvastatin, while pruritus arose in 35% of those on 25 mg daily and one patient with cirrhosis on this dose died of multiorgan failure during the open label extension phase).
Bowlus CL, Pockros PJ, Kremer AE, Parés A, Forman LM, Drenth JPH, Ryder SD, et al. (2019). Long-term obeticholic acid therapy improves histological endpoints in patients with primary biliary cholangitis. Clin Gastroenterol Hepatol. (Among 17 patients with PBC receiving ursodiol and OCA for 2-3 years while participating in an open label extension study of a randomized controlled trial [Trauner 2019], fibrosis stages worsened in 5 patients, were unchanged in 10 and improved in 2, although serum enzyme levels showed sustained improvement compared to baseline).
Trauner M, Nevens F, Shiffman ML, Drenth JPH, Bowlus CL, Vargas V, Andreone P, et al. (2019). Long-term efficacy and safety of obeticholic acid for patients with primary biliary cholangitis: 3-year results of an international open-label extension study. Lancet Gastroenterol Hepatol. (Among 193 patients with PBC entered into an open label extension study after a 48 week randomized controlled trial of OCA [Nevens 2016], serum enzyme improvements were sustained for up to 4 years and bilirubin levels were stable, although pruritus remained common [77%] and esophageal varices developed in 5% and ascites in 4%, but no patient died due to liver disease).
Eaton JE, Vuppalanchi R, Reddy R, Sathapathy S, Ali B, Kamath PS. (2019). Liver injury in patients with cholestatic liver disease treated with obeticholic acid. Hepatology. (Case series of 8 patients, 4 each with PBC or PSC, who developed hepatic decompensation while on OCA treatment, four undergoing liver transplantation, the remaining improving slowly after stopping OCA).

## OTHER REFERENCE LINKS

1 Recent References on Obeticholic Acid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Obeticholic+Acid/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Obeticholic Acid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Obeticholic+Acid)